# Maraviroc

## OVERVIEW

### Introduction

Maraviroc is a chemokine co-receptor 5 (CCR5) antagonist, the first of a new class of agents active against the human immunodeficiency virus (HIV) and the acquired immunodeficiency syndrome (AIDS). Maraviroc was approved for use in the United States in 2007 but has had limited use. Maraviroc has been associated with elevations in serum aminotransferase levels and to several cases of acute, clinically apparent liver injury.

### Background

Maraviroc (mar" a vir' ok) is relatively new antiretroviral drug that targets one of the receptors for HIV that is present on the surface of lymphocytes. Maraviroc interrupts the binding of HIV to target cells by blocking the chemokine coreceptor 5 (CCR5), a necessary receptor in the uptake of HIV into cells. Maraviroc has both in vitro and in vivo activity against HIV and several randomized controlled trials have shown that it leads to significant decline in HIV RNA levels and rises in peripheral CD4 T cell counts. Maraviroc was given accelerated approval for use in HIV infection in the United States in 2007 and is currently used in a relatively small proportion of antiretroviral regimens, being recommended largely for HIV-treatment experienced adult patients with CCR5-tropic strains of HIV. Maraviroc is available as 150 and 300 mg tablets generically and under the brand name Selzentry. The recommended dose is 150 to 600 mg twice daily in combination with other classes of antiretroviral agents. Common side effects include cough, fever, rash and dizziness. Rare but potentially severe adverse events include myocardial ischemia or infarction, hypotension, hepatotoxicity and severe hypersensitivity reactions including Stevens Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Therapy with maraviroc was associated with alanine aminotransferase (ALT) elevations in up to 10% of patients, but elevations above 5 times normal are less common. Furthermore, rates of ALT elevations with maraviroc were similar to rates in comparator groups receiving similar background optimized antiretroviral therapy [2.6% vs 3.4% above 5 times ULN in one study and 3.9% vs 4.0% in a second]. These elevations have not been associated with clinical symptoms and generally did not require dose modification. Nevertheless, two cases of acute hepatocellular injury arose in patients receiving maraviroc in prelicensure clinical trials. Both were women, ages 24 and 27, who developed fever, fatigue and rash followed by liver tests abnormalities within 1 to 3 weeks of starting maraviroc. One patient remained anicteric (peak bilirubin 1.5 mg/dL) while the other developed marked jaundice (peak bilirubin 31 mg/dL) and underwent emergency liver transplantation 16 days after onset. In both instances, other potential causes were present but no other diagnosis was confirmed. For these reasons, hepatitis and hepatic failure are listed as adverse events in the product label which includes a boxed warning about hepatotoxicity. Aplaviroc, the initial CCR5 antagonist developed, was abandoned during preclinical testing because of concerns about hepatotoxicity. The clinical features of hepatotoxicity related to maraviroc have not been described in detail and the drug has had limited use. There have been no further reports of liver failure attributed to maraviroc therapy.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Maraviroc is extensively metabolized in the liver via the CYP 450 system and is a substrate for P-glycoprotein, making it susceptible to multiple drug-drug interactions. Thus, liver injury from maraviroc may be due to its hepatic conversion to a toxic or immunogenic intermediate. The reported cases have had features suggestive of a hypersensitivity reaction.

### Outcome and Management

The serum aminotransferase abnormalities that occur during maraviroc therapy are usually mild and self-limited, not requiring dose modification or discontinuation. The course and outcome of more clinically apparent hepatotoxicity has not been characterized. There is unlikely to be any cross sensivity to hepatic injury between maraviroc and other antiretroviral agents.

Drug Class: Antiviral Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Maraviroc – Selzentry®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Maraviroc)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Maraviroc | 376348-65-1 | C29-H41-F2-N5-O | Maraviroc Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2019

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including maraviroc).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-57. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2007/022128_selzentry_toc.cfm. (FDA website with the formal review of the safety and efficacy of maraviroc with descriptions of the two patients who developed clinically apparent liver injury during the prelicensure clinical trials).
http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Horster S, Goebel FD. Serious doubts on safety and efficacy of CCR5 antagonists: CCR5 antagonists teeter on a knife-edge. Infection 2006; 34; 110-3. (Review of safety of CCR5 antagonists: aplaviroc, maraviroc and vicriviroc; among 336 patients enrolled in two studies of aplaviroc, 12 developed hepatotoxicity arising after an average of 13 weeks [1 coinfected with HBV and 1 with HCV] with jaundice in 4; a single case of acute liver failure arose after 4 doses of maraviroc in a patient on isoniazid and trimethoprim-sulfamethoxazole, but little evidence for a class effect in causing hepatotoxicity). 16703305
Crabb C. GlaxoSmithKline ends aplaviroc trials. AIDS 2006; 20: 641. (News article that Glaxo stopped trial of aplaviroc, a CCR5 inhibitor for HIV infection, after 3 patients given drug for 4 weeks developed ALT elevations; none had jaundice or developed liver failure). 16514292
Telenti A, Egger M. Identifying safety concerns from genetic data: lessons from the development of CCR5 inhibitors. Antivir Ther 2007; 12: 147-8. (Editorial discussing the safety of inhibition of CCR5; CCR5 plays an important role in host immune defenses and its inhibition may have adverse effects on susceptibility to other infections, although this has yet to be shown). 17503656
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Recommendations on use of antiviral therapy in adults with HIV infection including maraviroc). 18677028
Two new drugs for HIV infection. Med Lett Drugs Ther 2008; 50: 2-4. (Concise summary on the safety and efficacy of ralegravir and maraviroc in treatment-refractory or treatment-experienced patients with HIV infection; hepatotoxicity reported with maraviroc [with rash and eosinophilia], but not with raltegravir). 18197163
Gulick RM, Lalezari J, Goodrich J, Clumeck N, DeJesus E, Horban A, Nadler J, et al.; MOTIVATE Study Teams. Maraviroc for previously treated patients with R5 HIV-1 infection. N Engl J Med. 2008; 359: 1429-41. (Two controlled trials of maraviroc versus placebo combined with optimized antiretroviral therapy in 1049 patients treated for 48 weeks; there were "no significant differences in the rates of treatment-related adverse events"; ALT elevations >5 times ULN occurred in 3.5% on maraviroc vs 3.3% on placebo; no mention of clinically apparent hepatotoxicity). 18832244
Emmelkamp JM, Rockstroh JK. Maraviroc, risks and benefits: a review of the clinical literature. Expert Opin Drug Saf 2008; 7: 559-69. (Review of structure, mode of action, clinical efficacy and safety of maraviroc, the first CCR5 coreceptor antagonist approved for HIV infection; elevations in serum ALT levels occurred as frequently in control as in maraviroc-treated patients; discuss a case of acute liver failure occurring in a patient receiving maraviroc in registration trial who was also on isoniazid and trimethoprim-sulfamethoxazole). 18759708
Abel S, van der Ryst E, Rosario MC, Ridgway CE, Medhurst CG, Taylor-Worth RJ, Muirhead GJ. Assessment of the pharmacokinetics, safety and tolerability of maraviroc, a novel CCR5 antagonist, in healthy volunteers. Br J Clin Pharmacol 2008; 65 Suppl 1: 5-18. (Results of single and multiple dose pharmacokinetic studies of maraviroc in normal controls; no serious adverse events but ALT elevations occurred in 11% and levels were >3 times ULN in one; high dose arm was discontinued because of postural hypotension). 18333861
Hughes CA, Robinson L, Tseng A, MacArthur RD. New antiretroviral drugs: a review of the efficacy, safety, pharmacokinetics, and resistance profile of tipranavir, darunavir, etravirine, rilpivirine, maraviroc, and raltegravir. Expert Opin Pharmacother 2009; 10: 2445-66. (Review of tipranavir, darunavir, etravirine, rilpivirine, maraviroc and raltegravir; hepatotoxicity seen with aplaviroc does not appear to be a class effect and only one case of severe hepatotoxicity reported in registration trials of maraviroc; no differences in side effects in cohorts with HCV or HBV coinfection, but maraviroc was approved with a "black box" warning about hepatotoxicity). 19678794
Saag M, Goodrich J, Fäenheuer G, Clotet B, Clumeck N, Sullivan J, Westby M, et al.; A4001029 Study Group. A double-blind, placebo-controlled trial of maraviroc in treatment-experienced patients infected with non-R5 HIV-1. J Infect Dis 2009; 199: 1638-47. (Placebo controlled trial of maraviroc [in two doses] in 167 treatment-experienced patients with non-R5 strains of HIV [strains not requiring CCR5 for cell entry] for 24 weeks found no difference in HIV RNA suppression; ALT elevations >5 times ULN in 1% on maraviroc vs 5% on placebo and no clinically apparent liver injury or liver related deaths). 19432546
Ayoub A, Alston S, Goodrich J, Heera J, Hoepelman AI, Lalezari J, Mchale M, et al. Hepatic safety and tolerability in the maraviroc clinical development program. AIDS 2010; 24: 2743-50. (Summary of the hepatic safety of maraviroc from prelicensure controlled trials found no difference in rates of liver enzyme elevations between maraviroc and control treated arms; however, two participants had severe hepatotoxicity that was possibly related to maraviroc, but other potential causes of liver injury were present). 20935557
Sierra-Madero J, Di Perri G, Wood R, Saag M, Frank I, Craig C, Burnside R, et al. Efficacy and safety of maraviroc versus efavirenz, both with zidovudine/lamivudine: 96-week results from the MERIT study. HIV Clin Trials 2010; 11: 125-32. (In a controlled trial of maraviroc vs efavirenz combined with optimized background therapy continued to 96 weeks, ALT elevations >5 times ULN occurred in 4% of both groups, most elevations occurring during the first 48 weeks). 20736149
Hardy WD, Gulick RM, Mayer H, Fätkenheuer G, Nelson M, Heera J, Rajicic N, Goodrich J. Two-year safety and virologic efficacy of maraviroc in treatment-experienced patients with CCR5-tropic HIV-1 infection: 96-week combined analysis of MOTIVATE 1 and 2. J Acquir Immune Defic Syndr 2010; 55: 558-64. (In an extended treatment of patients in two controlled trials of maraviroc to 96 weeks, the rate of ALT elevations >3 times ULN per 100 patients years was 7.8 for maraviroc vs 10.0 for placebo combined with optimized background therapy). 20703158
Ortu F, Weimer LE, Floridia M, Manconi PE. Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res 2010; 15: 81-3. (43 year old woman with HIV/HCV coinfection who developed symptomatic elevations of serum enzymes on saquinavir, fosamprenavir and again on darunavir, was adequately maintained on tenofovir/emtricitabine and raltegravir). 20452889
Wasmuth JC, Rockstroh JK, Hardy WD. Drug safety evaluation of maraviroc for the treatment of HIV infection. Expert Opin Drug Saf 2012; 11: 161-74. (Systematic review of the safety of maraviroc from randomized controlled trials in the published literature and from presentations at meetings concluded that “no relevant toxicities or co-morbidities such as ... hepatotoxicty have been described”). 22118500
Lazzarin A, Than S, Valluri SR, Heera J, Mukwaya G. Safety profile of maraviroc in patients coinfected with HIV-1 and hepatitis B or C included in the maraviroc expanded access program. HIV Clin Trials 2012; 13: 83-9. (Analysis of maraviroc expanded access program of 1032 patients found hepatobiliary events more common in HIV-infected patients with HCV coinfection [10 vs 3.1 per 100 patient years]; rates of ALT elevations >5 times ULN were similar in patients receiving expanded access maraviroc vs placebo recipients in the Motivate trial [Hardy 2010] including those with HIV monoinfection [1.5% vs 3.1%], HIV/HBV coinfection [5.9% vs 8.3%] and HIV/HCV coinfection [8.7% vs 3.3%]). 22510355
Mangiafico L, Perja M, Fusco F, Riva S, Mago D, Gringeri A. Safety and effectiveness of raltegravir in patients with haemophilia and anti-HIV multidrug resistance. Haemophilia 2012; 18: 108-11. (Among 7 patients with hemophilia and HIV-HCV coinfection on antiretroviral regimens including raltegravir, only 1 had an increase in liver enzyme levels and “cholestasis”, which resolved promptly when maraviroc was discontinued while raltegravir was continued). 21762404
Surgers L, Lacombe K. Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol 2013; 37: 126-33. (Review of the rates of liver test abnormalities in large clinical trials of new antiretroviral agents [etravirine, rilpivirine, maraviroc, raltegravir, elvitegravir, dolutegravir and darunavir] concludes that "the overall hepatic tolerance is far bettter with the novel drugs in this review than with former ARV regimens"; only darunavir and maraviroc had warnings about liver injury when they were released). 23522569
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] cases were attributed to antiretroviral agents, but none to the maraviroc or other CCR5 coreceptor antagonists). 25754159
Neukam K, Mira JA, Collado A, Rivero-Juárez A, Monje-Agudo P, Ruiz-Morales J, Ríos MJ, et al; HEPAVIR SEG-HEP-2007 Study Group of the Sociedad Andaluza de Enfermedades Infecciosas (SAEI). Liver toxicity of current antiretroviral regimens in HIV-infected patients with chronic viral hepatitis in a real-life setting: The HEPAVIR SEG-HEP Cohort. PLoS One 2016; 11: e0148104. (Among 192 "real-life" patients with HIV who were coinfected with HBV or HCV and were started on a new antiretroviral regimen, 10 [5%] developed ALT or AST elevations above 5 times ULN, including 1 of 9 started on maraviroc, but none required drug discontinuation because of the elevations or developed clinically apparent liver injury). 26848975
Rockstroh JK, Plonski F, Bansal M, Fätkenheuer G, Small CB, Asmuth DM, Pialoux G, et al. Hepatic safety of maraviroc in patients with HIV-1 and hepatitis C and/or B virus: 144-week results from a randomized, placebo-controlled trial. Antivir Ther 2017; 22: 263-9. (Among 137 patients with HIV and HBV or HCV coinfection who were treated with maraviroc or placebo in addition to their standard antiretroviral regimen for 144 weeks, rates of ALT or AST elevations and hepatobiliary adverse events were similar in the two groups). 27924779
Bunchorntavakul C, Reddy KR. Drug Hepatotoxicity: Newer Agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of selected newly approved medications including maraviroc which was implicated in a few cases of hepatotoxicity including acute liver failure in prelicensure clinical trials). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Maraviroc: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Maraviroc/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Maraviroc: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Maraviroc)